# Daridorexant

## OVERVIEW

### Introduction

Daridorexant is an orexin receptor antagonist currently used in the treatment of insomnia in adults. Daridorexant is associated with rare instances of elevations in serum aminotransferase levels during therapy but has not been implicated in cases of clinically apparent liver injury.

### Background

Daridorexant (da ree” doe rex’ ant) is an orexin receptor antagonist used for therapy of insomnia in adults. Orexin is a neuropeptide that plays a role in wakefulness and central nervous system neurons, with orexin receptors that are activated during wakeful periods and are inactive during sleep. Engagement of the orexin receptor results in wakefulness, and loss of the receptor can result in excessive daytime sleepiness and narcolepsy. Antagonism of orexin receptors causes somnolence and promotes sleep. In several randomized controlled trials, daridorexant shortened the latency to onset of sleep and helped maintain sleep, prolonging the time to wake after sleep onset. Daridorexant was approved for use in the United States in 2022, the third orexin receptor antagonist made available (suvorexant 2014 and lemborexant 2019). Daridorexant is available under the brand name Quviviq in tablets of 25 and 50 mg, the recommended dose in adults being 25 mg taken within 30 minutes of bedtime. The dose can be raised to 50 mg but higher doses should not be used. Side effects are usually mild but can include headache, somnolence, and fatigue. Daridorexant taken before bedtime can also cause some degree of daytime somnolence, impairment of driving or using heavy machinery. Uncommon (occurring in less than 1% of persons) but potentially troublesome adverse events include sleep paralysis and complex sleep behaviors (such as sleepwalking and hallucinations). Daridorexant can also worsen depression and decrease respiratory function and should be used with caution in persons on antidepressants or with respiratory dysfunction. Daridorexant is classified as a Schedule 4 controlled substance, meaning that it has a low potential for abuse or dependence and has an approved medical use.

### Hepatotoxicity

In two controlled trials conducted in support of approval of daridorexant in the United States, there were no changes in serum ALT, AST, alkaline phosphatase or bilirubin levels during treatment and no instances of drug induced liver injury. Since its approval and more widespread clinical use, there have been no published reports of clinically apparent liver injury attributed to daridorexant. Indeed, the two previously approved orexin receptor antagonists available in the United States were also found to be free of hepatic adverse effects.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which daridorexant might cause serum aminotransferase elevations is not known. It is metabolized in the liver by the P450 system, largely by CYP 3A4 and is susceptible to drug-drug interactions. The dose of daridorexant may have to be adjusted if there is concurrent therapy with moderate or strong CYP 3A4 inhibitors (which can increase daridorexant levels) or inducers (which could lower levels of daridorexant).

### Outcome and Management

There is no evidence that daridorexant can cause liver injury, and development of ALT or AST elevations or clinical evidence of liver injury during therapy should lead to search for another cause.

Drug Class: Sedatives and Hypnotics; Drugs for Insomnia

Other Orexin Receptor Antagonists: Lemborexant, Suvorexant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daridorexant – Quviviq®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Daridorexant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Daridorexant | 1505484-82-1 | C23-H23-ClN6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 February 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of orexin receptor antagonists).
Larrey D, Ripault MP. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian, all of which have been linked to rare cases of liver injury; daridorexant and other orexin receptor antagonists are not discussed).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-353. (Textbook of pharmacology and therapeutics, discusses suvorexant but not daridorexant).
FDA. Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/214985Orig1s000IntegratedR.pdf (FDA website with product labels and FDA review of the data on efficacy and safety submitted by the sponsor in support of the approval of daridorexant mentions side effects of somnolence, headache, and fatigue; no mention of ALT elevations or hepatotoxicity, but there was “no indication of any potential effect of daridorexant on laboratory values” including liver function tests).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to drugs for insomnia). 25754159
Muehlan C, Heuberger J, Juif PE, Croft M, van Gerven J, Dingemanse J. Accelerated development of the dual orexin receptor antagonist ACT-541468: integration of a microtracer in a first-in-human study. Clin Pharmacol Ther. 2018;104:1022-1029. (Analysis of the absorption, bioavailability, pharmacokinetics, metabolism, and tolerance of daridorexant in 40 healthy volunteers, in whom side effects were mild-to-moderate only and included somnolence, fatigue, disturbance in concentration, and headache). 29446069
Mignot E, Mayleben D, Fietze I, Leger D, Zammit G, Bassetti CLA, Pain S, et al.; investigators. Safety and efficacy of daridorexant in patients with insomnia disorder: results from two multicentre, randomised, double-blind, placebo-controlled, phase 3 trials. Lancet Neurol. 2022;21:125-139. (Among 1854 adults with insomnia treated with daridorexant [10, 25, or 50 mg] or placebo once before bedtime for 3 months, latency to sleep onset and maintenance of sleep increased with the higher doses by an average of 10-20 minutes compared to placebo, while side effects included headache [4%-6% vs 4%), fatigue [2%-4% vs 1%] somnolence [2%-4% vs 2%]; no mention of ALT elevations or hepatotoxicity). 35065036
Daridorexant (Quviviq) for insomnia. Med Lett Drugs Ther. 2022;64:107-110. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of daridorexant shortly after its approval as therapy for insomnia in the US mentions adverse events of headache, somnolence, and fatigue [5%-7%] and more rarely daytime sleepiness, sleep paralysis, and hallucinations [<1%]; no mention of ALT elevations or hepatotoxicity). 35802843
Kunz D, Dauvilliers Y, Benes H, García-Borreguero D, Plazzi G, Seboek Kinter D, et al. Long-term safety and tolerability of daridorexant in patients with insomnia disorder. CNS Drugs. 2023;37:93-106. (Among 801 adults with insomnia who participated in a 12-week controlled trial of daridorexant who were enrolled in a 40-week extension trial, improvements in sleep were sustained and adverse events remained mild and infrequent including falls, headache and somnolence in <3%, and dizziness and fatigue <2%, and there were “no clinically significant findings for any changes in hematology or chemistry parameters”). 36484969
Drugs for chronic insomnia. Med Lett Drugs Ther. 2023;65:1-6. (Concise description of drugs approved for use in chronic insomnia including relative efficacy, safety and costs, mentions that daridorexant like other orexin receptor inhibitors improves latency to falling asleep by 5-10 minutes and duration of sleep to waking by 15 to 25 minutes compared to placebo, and that the most common adverse events are somnolence, fatigue, headache, and abnormal dreams). 36630579
Preskorn SH. Comparative pharmacology of the 3 marketed dual orexin antagonists-daridorexant, lemborexant, and suvorexant-part 2. principal drug metabolizing enzyme, drug-drug interactions, and effects of liver and renal impairment on metabolism. J Psychiatr Pract. 2023;29:38-41. (Review of the pharmacokinetics of the 3 orexin antagonists in clinical use, including suvo-, lembo-, and darido-rexant, mentions that they have similar chemical structures and similar metabolism by CYP 3A4, with only minor differences in susceptibility to inducers and inhibitors of CYP 3A4). 36649550
Pan B, Ge L, Lai H, Hou L, Tian C, Wang Q, Yang K, et al. The comparative effectiveness and safety of insomnia drugs: a systematic review and network meta-analysis of 153 randomized trials. Drugs. 2023;83:587-619. (Systematic review of the literature on the safety of drugs for insomnia identified 61 trials with 25,093 patients, and while the frequency of common adverse events varied, “with respect to serious and drug related adverse events, there were no differences among the drugs’; no mention of liver related adverse events). 36947394
Wang Q, Zhou Q, Du Z, Lu R, Jiang Y, Zhu H. Clinical safety of daridorexant in insomnia treatment: Analysis of FDA adverse event reports. J Affect Disord. 2024;362:552-559. (Among 1854 spontaneous reports to the FDA’s Adverse Event Reporting System between 2022 and 2023 implicating daridorexant, most were for general disorders, psychiatric and neurologic events, only 3 were “hepatobiliary”; no details provided). 39019232

## OTHER REFERENCE LINKS

1. Recent References on Daridorexant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Daridorexant/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Daridorexant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Daridorexant)